# Zanamivir

## OVERVIEW

### Introduction

Zanamivir is an inhibitor of the influenza neuraminidase enzyme and is given by inhalation as therapy and prophylaxis against influenza A and B. Zanamivir has not been associated with clinically apparent liver injury, at least when given by inhalation.

### Background

Zanamivir (za nam' i vir) is a sialic acid analogue and a potent inhibitor of the neuraminidase of influenza viruses. Inhibition of this enzyme causes a decrease in viral replication, probably as a result of interference with particle formation and release. Zanamivir is active against both influenza A and B viruses, but has no activity against other common upper respiratory tract viruses. In addition, resistance to zanamivir can develop rapidly. Zanamivir is indicated for therapy or post-exposure prevention of influenza A or B. Zanamivir was approved in the United States in 1999 and is frequently used during influenza outbreaks. Zanamivir is available as a powder for inhalation (5 mg/blister pack) under the brand name of Relenza. The recommended dose for therapy in adults is 2 oral inhalations of 10 mg each, twice daily for 5 days; the usual prophylactic regimen is 10 mg once daily for 10 days, starting within 2 days of close contact with an infected person or for 28 days in a community setting. Side effects are uncommon and include mild nausea, dizziness, headache, cough, nasal and throat irritation and bronchospasm. Rare but potentially severe adverse reactions include hypersensitivity reactions, severe bronchospasm and neuropsychiatric syndromes including disorientation, hallucinations and mania.

### Hepatotoxicity

In randomized controlled trials, 2% to 3% of zanamivir recipients developed ALT or AST elevations above twice the upper limit of the normal range, but a similar rate was found in placebo-treated patients. Despite widespread use, there is little evidence that zanamivir when used by inhalation causes liver injury, either in the form of asymptomatic serum enzyme elevations or clinically apparent liver disease. In pilot studies of intravenous zanamivir for severe influenza, serum enzyme elevations have been reported in ~10% of patients, occasionally with jaundice, but the role of zanamivir versus the underlying severe viral infection has not been defined.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Zanamivir has little hepatic metabolism and does not affect cytochrome P450 (CYP) activity. The typical course of zanamivir is for 5 to 10 days only, and the brief exposure and minimal hepatic metabolism may account for its absence of hepatotoxicity when given by inhalation.

Drug Class: Antiviral Agents

Other Drugs in the Class for Influenza: Amantadine, Baloxavir, Oseltamivir, Peramivir, Rimantadine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Zanamivir – Relenza®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Zanamivir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Zanamivir | 139110-80-8 | C12-H20-N4-O7

## ANNOTATED BIBLIOGRAPHY

References updated: 22 June 2020

Zimmerman HJ. Antiviral agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 621-3. (Expert review of antiviral agents and liver injury published in 1999; amantadine and rimantadine have not caused "overt hepatic injury" and oseltamivir and zanamivir are not mentioned).
Núñez M. Influenza virus treatments. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 513. (Review of hepatotoxicity of antiviral agents; zanamivir is not discussed).
Acosta EP. Antiviral agents (nonretroviral). In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1105-18. (Textbook of pharmacology and therapeutics).
Hayden FG, Osterhaus AD, Treanor JJ, Fleming DM, Aoki FY, Nicholson KG, Bohnen AM, et al. (1997). Efficacy and safety of the neuraminidase inhibitor zanamivir in the treatment of influenza virus infections. GG167 Influenza Study Group. N Engl J Med. (Two controlled trials of 5 day course of zanamivir or placebo in 417 adults with an influenza-like illness; "No drug-related effects on blood counts, blood chemical values, or urinalysis results were found").
(1998). Randomised trial of efficacy and safety of inhaled zanamivir in treatment of influenza A and B virus infections. The MIST (Management of Influenza in the Southern Hemisphere Trialists) Study Group. Lancet. (Controlled trial of 5 day course of zanamivir vs placebo in 455 patients with influenza-like symptoms; "Laboratory results and vital signs did not differ between the two groups").
Freund B, Gravenstein S, Elliott M, Miller I. (1999). Zanamivir: a review of clinical safety. Drug Saf. (Extensive review of safety and tolerance of zanamivir given by inhalation; ALT and AST elevations above twice the upper limit of normal occurred in 2-3% of zanamivir and 2% of placebo recipients; no mention of clinically apparent liver injury).
McNicholl IR, McNicholl JJ. (2001). Neuraminidase inhibitors: zanamivir and oseltamivir. Ann Pharmacother. (Review of efficacy and safety of both zanamivir and oseltamivir; no mention of hepatotoxicity or ALT elevations).
Kaji M, Fukuda T, Tanaka M, Aizawa H. (2005). A side effect of neuraminidase inhibitor in a patient with liver cirrhosis. J Infect Chemother. (Two patients [a man and a woman, ages 66 and 70] with cirrhosis and hepatocellular carcinoma received zanamivir after exposure to influenza and developed rash and fever 1-2 days later, but without any changes in the already elevated serum enzymes and bilirubin).
Jefferson T, Demicheli V, Rivetti D, Jones M, Di Pietrantonj C, Rivetti A. (2006). Antivirals for influenza in healthy adults: systematic review. Lancet. (Analysis of 51 reports of 52 controlled trials of antivirals for influenza; "Neuraminidase inhibitors are not associated with any adverse events when used as treatment as opposed to prophylaxis").
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the United States collected between 2004 and 2008, 8 were attributed to antiviral agents, but none to anti-influenza medications).
(2009). Antiviral drugs for influenza. Med Lett Drugs Ther. (Review of status of antiviral agents for prevention and treatment of influenza A and B; no mention of hepatic toxicity of any of the anti-influenza agents).
(2013). Antiviral drugs. Treat Guidel Med Lett. (Review of status of non-antiretroviral antiviral agents; no mention of hepatotoxicity in discussion of side effects of zanamivir).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to a drug used to treat influenza).
Heneghan CJ, Onakpoya I, Thompson M, Spencer EA, Jones M, Jefferson T. (2014). Zanamivir for influenza in adults and children: systematic review of clinical study reports and summary of regulatory comments. BMJ. (Systematic review of 26 clinical trials of zanamivir for treatment and prevention of influenza found no evidence for increased risk of harm or adverse events).
Marty FM, Man CY, van der Horst C, Francois B, Garot D, Mánez R, Thamlikitkul V, et al. (2014). Safety and pharmacokinetics of intravenous zanamivir treatment in hospitalized adults with influenza: an open-label, multicenter, single-arm, phase II study. J Infect Dis. (Among 130 adults with influenza treated with intravenous zanamivir for a median of 5 days, acute, but self-limited liver injury was reported in 17 patients [13%] and was considered severe in 3 [2%] based upon ALT levels above 3 times ULN and jaundice).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 cases [1.3%] were attributed to antiviral agents, but none to antivirals used to treat influenza).
Chan-Tack KM, Kim C, Moruf A, Birnkrant DB. (2015). Clinical experience with intravenous zanamivir under an Emergency IND program in the United States (2011-2014). Antivir Ther. (Among 364 patients with severe, life-threatening influenza who received emergency authorization for zanamivir therapy between 2011 and 2014, 87% required mechanical ventilation and among 135 with outcome data, the mortality rate was 62% and the adverse event rate 43% [23/53 with data] including 7 patients with “increasing liver function tests”).
Marty FM, Vidal-Puigserver J, Clark C, Gupta SK, Merino E, Garot D, Chapman MJ, et al. (2017). Intravenous zanamivir or oral oseltamivir for hospitalized patients with influenza: an international, randomised, double-blind, double-dummy, phase 3 trial. Lancet Respir Med. (Among 626 patients with symptoms of influenza [488 confirmed] treated with zanamivir [300 or 600 mg] or oseltamivir twice daily for 5-10 days, time to clinical improvement was similar in all three groups as were adverse events including respiratory failure and death; ALT elevations arose in 1.2% of zanamivir vs 2.0% of oseltamivir treated subjects).
Bradley JS, Blumer JL, Romero JR, Michaels MG, Munoz FM, Kimberlin DW, Pahud B, et al. (2017). Intravenous zanamivir in hospitalized patients with influenza. Pediatrics. (Among 71 children hospitalized for severe influenza treated with zanamivir twice daily for median of 5 days, clinical improvement occurred in most, 5 children died [7%] and treatment related adverse events were similar to those described in adults, and “no clinically significant trends were observed for ALT or total bilirubin levels”).
Cleary PR, Crofts J, Parry-Ford F, Chand M, Phin N. (2019). Characteristics and mortality of severe influenza cases treated with parenteral aqueous zanamivir, United Kingdom, October 2009 to January 2011. Influenza Other Respir Viruses. (Among 185 patient with laboratory confirmed severe influenza treated with intravenous zanamivir for up to 21 days during the 2009-2011 influenza seasons in the UK, 55% recovered, 10% had permanent sequelae and 34% died; “some adverse events were noted’ but it “was not possible to distinguish the effects of zanamivir from progression of disease”).
(2019). Antiviral drugs for treatment and prophylaxis of seasonal influenza. Med Lett Drugs Ther. (Concise review of the drug therapy of influenza mentions that there are no data suggesting the superiority of one drug over another, they are all approved for treatment of uncomplicated influenza, should be started as soon as possible, and have been shown to shorten the duration of symptoms by one day in adults; no mention of ALT elevations or hepatotoxicity of any of the neuraminidase inhibitors).
(2020). Antiviral drugs for influenza. Med Lett Drugs Ther. (Concise review of the drug therapy for treatment and prevention of influenza mentions that zanamivir is approved as inhalation therapy twice daily for 5 days for treatment and once daily for 7 days for prevention, and adverse events can include diarrhea, nausea, sinusitis, fever, arthralgia and bronchospasm; no mention of ALT elevations or hepatic adverse events).

## OTHER REFERENCE LINKS

1 Recent References on Zanamivir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Zanamivir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Zanamivir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Zanamivir)